# Cevimeline

## OVERVIEW

### Introduction

Cevimeline is an orally available cholinergic agonist that is used to treat symptoms of dry mouth in patients with keratoconjunctivitis sicca (Sjögren syndrome). Cevimeline has not been linked to serum enzyme elevations during therapy or to instances of clinically apparent liver injury.

### Background

Cevimeline (se vim' e leen) is a quinuclidine derivative of acetylcholine which acts as a cholinergic muscarinic agonist. Engagement of the muscarinic cholinergic receptors causes increased secretion from exocrine glands, including sweat, salivary, lacrimal, gastric, pancreatic and intestinal glands, as well as increase smooth muscle tone and motility in the eye, respiratory tract and gastrointestinal tract. Use of daily doses of cevimeline has been shown to improve symptoms of dry mouth and increase salivary flow in patients with Sjögren syndrome and with xerostomia due to local irradiation therapy. Cevimeline was approved for use in the United States in 2000 and is available in capsules of 30 mg generically and under the brand name Evoxac. The typical dose is 30 mg three times daily. Side effects are usually mild and largely attributable to cholinergic stimulation including increased sweating, rhinitis, nausea, diarrhea, headaches, dizziness, visual disturbances and fatigue.

### Hepatotoxicity

In prelicensure trials of cevimeline, serum enzyme elevations were no more frequent than with placebo and there were no reports of acute liver injury. Since licensure and more wide scale use, cevimeline has remained free of association with instances of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which cevimeline might cause serum aminotransferase elevations is not known. Cevimeline is metabolized by the liver predominantly by the cytochrome P450 system, CYP 2D6 and 3A4, but neither inhibits nor induces the microsomal enzymes.

Drug Class: Sjögren Syndrome Agents, Cholinergic Agents

Other Drugs in the Class: Pilocarpine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cevimeline – Evoxac®

DRUG CLASS

Sjögren Syndrome Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Cevimeline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cevimeline | 107233-08-9 | C10-H17-N-O-S | Cevimeline Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 23 January 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Extensive review of hepatotoxicity published in 1999; cholinergic agents and cevimeline are not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook of hepatotoxicity published in 2013; cholinergic agents and cevimeline are not discussed).
Brown JH, Laiken N. Muscarinic receptor agonists and antagonists. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 219-37. (Textbook of pharmacology and therapeutics).
Cevimeline(Evoxac) for dry mouth. Med Lett Drugs Ther 2000; 42(1084): 70. (Concise review of mechanism of action, pharmacokinetics, efficacy, safety and cost of cevimeline, mentions side effects of sweating, nausea, rhinitis, diarrhea and visual disturbances; no mention of ALT elevations or hepatotoxicity). 10932302
Fife RS, Chase WF, Dore RK, Wiesenhutter CW, Lockhart PB, Tindall E, Suen JY. Cevimeline for the treatment of xerostomia in patients with Sjögren syndrome: a randomized trial. Arch Intern Med 2002; 162: 1293-300. (Controlled trial of 2 doses [30 and 60 mg three times daily] for 6 weeks in 75 patients with Sjögren syndrome showed dose related decrease in symptoms of dry mouth and increase in salivary flow; side effects were largely those of cholinergic stimulation and "there were no apparent dose-related changes in mean laboratory values"). 12038948
Petrone D, Condemi JJ, Fife R, Gluck O, Cohen S, Dalgin P. A double-blind, randomized, placebo-controlled study of cevimeline in Sjögren's syndrome patients with xerostomia and keratoconjunctivitis sicca. Arthritis Rheum 2002; 46: 748-54. (Controlled trial of 2 doses of cevimeline [15 and 30 mg three times daily] versus placebo in 197 patients with Sjögren syndrome showed dose related improvements in dry mouth and salivary flow and "there were no significant dose-related changes in mean laboratory values"). 11920411
Fox RI. Sjögren's syndrome: evolving therapies. Expert Opin Investig Drugs 2003; 12: 247-54. (Review of standard and experimental therapies of Sjögren syndrome mentions cevimeline, but does not discuss its adverse side effects). 12556218
Ono M, Takamura E, Shinozaki K, Tsumura T, Hamano T, Yagi Y, Tsubota K. Therapeutic effect of cevimeline on dry eye in patients with Sjögren's syndrome: a randomized, double-blind clinical study. Am J Ophthalmol 2004; 138: 6-17. (Among 60 patients with Sjögren syndrome who were treated cevimeline [20 or 30 mg three times daily] or placebo for 4 weeks, the most frequent side effects were diarrhea, nausea, dyspepsia, and headache; no mention of ALT elevations or hepatotoxicity). 15234277
Chambers MS, Jones CU, Biel MA, Weber RS, Hodge KM, Chen Y, Holland JM, et al. Open-label, long-term safety study of cevimeline in the treatment of postirradiation xerostomia. Int J Radiat Oncol Biol Phys 2007; 69: 1369-76. (Among 255 patients with post-irradiation xerostomia who were treated with cevimeline [45 mg three times daily] for 6 months, common side effects were sweating [48%], dyspepsia [9%], nausea [8%] and diarrhea [6%]; mild elevations in ALT occurred, but were less than twice ULN). 17855005
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to cevimeline). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cevimeline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cevimeline+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cevimeline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cevimeline)